# Liver Biopsy

Liver biopsy can be helpful in the assessment of suspected drug induced liver disease, but is usually not necessary unless an important therapeutic or diagnostic decision rests upon rapid establishment of the diagnosis. Thus, liver biopsy can be helpful in assessing acute onset of liver disease after bone marrow transplantation, so as to distinguish drug induced sinusoidal obstruction syndrome from the graft-vs-host syndrome that would require change in the immunosuppressive regimen. Similarly, in situations where the implicated medication is considered necessary or life supporting, liver biopsy may be helpful in making a decision about the likelihood of drug induced liver injury. Examples of situations in which liver biopsy can be extremely helpful diagnostically include acetaminophen as a cause of acute liver injury and methotrexate or amiodarone as a cause of apparent chronic liver disease. In most situations, however, a liver biopsy is largely supportive of the diagnosis and not absolutely essential in patient management.